# Naltrexone

## OVERVIEW

### Introduction

Naltrexone is a synthetic opioid antagonist used in prevention of relapse of opiate addiction and alcoholism. Naltrexone has been associated with low rates of serum enzyme elevations during therapy and with rare instances of clinically apparent liver injury.

### Background

Naltrexone (nal trex' one) is orally available opioid antagonist which blocks the euphoric effects of administered opiates. Naltrexone is a relatively pure antagonist and has no analgesic activity. Naltrexone has been shown to aid in maintenance of an opioid-free state in detoxified patients and to help in other addictions. Naltrexone was approved for use in the therapy of opioid and alcohol dependence in the United States in 1984. Naltrexone is available in tablets of 50 mg in several generic formulations and under the brand name Revia. More recently, injectable suspensions of naltrexone (Vivitrol), injectable implants and solutions of methylnaltrexone (Relistor) have become available for therapy of opioid dependence. Fixed combinations of naltrexone and bupropion (Contrave) have been approved as a weight loss agent. The usually recommended dose of the oral preparation is 50 mg daily. The injectable suspension is given intramuscularly and the solution subcutaneously every 4 weeks. Naltrexone must be started carefully in patients with opioid abuse to avoid precipitous withdrawal reactions. The most common side effects are headache, sleep disturbance, anxiety, dizziness, nausea, diarrhea and rash.

### Hepatotoxicity

Naltrexone therapy is typically given to patients with a high background rate of liver disease (injection drug use or alcoholism) and has been associated with variable rates of serum enzyme elevations (0% to 50%), values above 3 times the upper limit of normal occurring in approximately 1% of patients and occasionally leading to drug discontinuation. However, several studies have shown that the rate of ALT elevations during naltrexone therapy is similar to that with placebo. Most serum aminotransferase elevations during naltrexone therapy are mild and self-limiting, resolving even with continuation of therapy. While several rare instances of acute, clinically apparent liver disease have been reported in patients taking naltrexone, the role of the medication in the liver injury has not always been clear and there has been no clear description of the clinical features of the injury. Thus, while often considered hepatotoxic, naltrexone has not been definitively linked to cases of clinically apparent liver injury.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

Naltrexone is a relatively pure opioid antagonist and is rapidly metabolized by the liver to inactive forms. The cause of hepatic injury is not known, but may be partially dose dependent direct toxicity.

Agents in clinical use in therapy of alcohol abuse and dependence include acamprosate, disulfiram, methadone, and naltrexone.

Drug Class: Substance Abuse Treatment Agents; Opioid Antagonists

Other Drugs in the Class, Opioid Antagonists: Nalmefene, Naloxegol, Naloxone

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Naltrexone – Generic, Revia®, Vivitrol®

DRUG CLASS

Substance Abuse Treatment Agents; Opioid Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Naltrexone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Naltrexone | 16590-41-3 | C20-H23-N-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 24 March 2020

Zimmerman HJ. Narcotic analgesics. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 710-11. (Expert review of hepatotoxicity published in 1999; mentions that trials of naltrexone have reported serum aminotransferase elevations in up to 30% of recipients, an effect that appeared to be partially dose dependent).
Larrey D, Ripault MP. Illegal and recreational compounds. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 456-7. (Review of hepatotoxicity of drugs of abuse, does not discuss naltrexone).
O’Brien CP. Drug use disorders and addiction. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 433-41. (Textbook of pharmacology and therapeutics).
Atkinson RL, Berke LK, Drake CR, Bibbs ML, Williams FL, Kaiser DL. (1985). Effects of long-term therapy with naltrexone on body weight in obesity. Clin Pharmacol Ther. (Modest increases in serum aminotransferase levels occurred in some patients receiving naltrexone in doses of 50-100 mg daily).
Jonas JM, Gold MS. (1988). The use of opiate antagonists in treating bulimia: a study of low-dose versus high-dose naltrexone. Psychiatry Res. (Open label study of two doses of naltrexone in 16 patients with bulimia; an effect was found with high dose; one patient had elevated ALT level [64 U/L] at week 6, resolving within 3 weeks of lowering the dose).
Mitchell JE. (1986). Naltrexone and hepatotoxicity. Lancet. (Among 26 patients with obesity treated with naltrexone [300 mg/day] for 3 weeks, 5 had serum aminotransferase elevations, all of which resolved on drug discontinuation; no details provided).
Dixon R, Gentile J, Hsu HB, Hsiao J, Howes J, Garg D, Weidler D. (1987). Nalmefene: safety and kinetics after single and multiple oral doses of a new opioid antagonist. J Clin Pharmacol. (Phase 1 study of safety of single injections and 7 day courses of nalmefene in different doses found no increases in serum aminotransferase levels).
Campbell M, Anderson LT, Small AM, Locascio JJ, Lynch NS, Choroco MC. (1990). Naltrexone in autistic children: a double-blind and placebo-controlled study. Psychopharmacol Bull. (Controlled trial of naltrexone for 14 days in 18 autistic children; "liver function tests ... remained within normal limits").
Hetrick WP, Krutzik MN, Taylor DV, Sandman CA, Rusu L, Martinazzi VP. (1993). Naltrexone has no hepatotoxic effects in a self-injurious patient with chronic hepatitis. J Clin Psychopharmacol. (28 year old male self-injurious patient with chronic hepatitis B was monitored carefully during 4 month course of oral naltrexone and had no worsening of serum enzymes or bilirubin levels).
Sax DS, Kornetsky C, Kim A. (1994). Lack of hepatotoxicity with naltrexone treatment. J Clin Pharmacol. (Prospective monitoring of liver tests in 10 patients with chorea treated with naltrexone for 10 to 36 months found no overall change in mean ALT or AST levels, but minor elevations in 2 patients [peak ALT 80 and 105 U/L] that resolved despite continuing therapy at increasing doses).
Mason BJ, Ritvo EC, Morgan RO, Salvato FR, Goldberg G, Welch B, Mantero-Atienza E. (1994). A double-blind, placebo-controlled pilot study to evaluate the efficacy and safety of oral nalmefene HCl for alcohol dependence. Alcohol Clin Exp Res. (Controlled trial of 12 weeks of nalmefene or placebo in 21 alcohol dependent patients, found no difference in laboratory measures during therapy, serum ALT levels decreasing in abstinent patients).
Kolmen BK, Feldman HM, Handen BL, Janosky JE. (1995). Naltrexone in young autistic children: a double-blind, placebo-controlled crossover study. J Am Acad Child Adolesc Psychiatry. (Controlled trial in 13 children with autism found no differences in hepatic enzymes during therapy with naltrexone vs placebo).
Croop RS, Faulkner EB, Labriola DF. (1997). The safety profile of naltrexone in the treatment of alcoholism. Results from a multicenter usage study. The Naltrexone Usage Study Group. Arch Gen Psychiatry. (Controlled trial of naltrexone vs placebo in 865 alcohol dependent patients; common side effects were nausea and headache; ALT levels tended to decrease during therapy and were similar in the two groups: "No clinically important abnormalities were noted...", but 3 patients stopped naltrexone early because of ALT elevations [156, 162 and 563 U/L at weeks 2-8 of therapy], which resolved rapidly thereafter).
Marrazzi MA, Wroblewski JM, Kinzie J, Luby ED. (1997). High-dose naltrexone and liver function safety. Am J Addict. (Controlled cross-over trial of 6 weeks of naltrexone [200-400 mg/day] vs placebo in 21 patients with eating disorders, found no elevations in aminotransferase levels during therapy).
Foss JF, O'Connor MF, Yuan CS, Murphy M, Moss J, Roizen MF. (1997). Safety and tolerance of methylnaltrexone in healthy humans: a randomized, placebo-controlled, intravenous, ascending-dose, pharmacokinetic study. J Clin Pharmacol. (Single, ascending dose study of methyl-naltrexone [which does not cross the blood-brain barrier] in 8 healthy volunteers found no changes in liver tests; dose limiting side effects being dizziness and orthostatic hypotension).
Metze D, Reimann S, Beissert S, Luger T. (1999). Efficacy and safety of naltrexone, an oral opiate receptor antagonist, in the treatment of pruritus in internal and dermatological diseases. J Am Acad Dermatol. (Among 50 patients with pruritus of varying etiologies treated with open-label naltrexone for up to 12 months, side effects included nausea, fatigue, dizziness and diarrhea; liver tests were done, but results were not discussed).
Bergasa NV, Schmitt JM, Talbot TL, Alling DW, Swain MG, Turner ML, Jenkins JB, et al. (1998). Open-label trial of oral nalmefene therapy for the pruritus of cholestasis. Hepatology. (Open label trial of nalmefene for 2-26 months in 14 patients with liver disease and pruritus found "no consistent effect of nalmefene on the severity of cholestasis, as assessed by routine serum biochemical markers").
Wong GY, Wolter TD, Croghan GA, Croghan IT, Offord KP, Hurt RD. (1999). A randomized trial of naltrexone for smoking cessation. Addiction. (Among 100 cigarette smokers receiving placebo or naltrexone with or without nicotine patches, side effects included headache and sleep disturbance, but no mention of effects on laboratory tests).
Chick J, Anton R, Checinski K, Croop R, Drummond DC, Farmer R, Labriola D, et al. (2000). A multicentre, randomized, double-blind, placebo-controlled trial of naltrexone in the treatment of alcohol dependence or abuse. Alcohol Alcohol. (Among 175 patients with alcoholism treated with naltrexone vs placebo for 12 weeks, ALT levels were no different in the two groups, while GGT levels were lower with naltrexone therapy).
Gastpar M, Bonnet U, Böning J, Mann K, Schmidt LG, Soyka M, Wetterling T, et al. (2002). Lack of efficacy of naltrexone in the prevention of alcohol relapse: results from a German multicenter study. J Clin Psychopharmacol. (Controlled trial of 12 weeks of naltrexone vs placebo in 171 detoxified alcoholic patients found similar rates of abstinence in the two groups, but greater decrease in GGT levels with naltrexone; one placebo recipient had significant ALT elevations).
Terg R, Coronel E, Sordá J, Muñoz AE, Findor J. (2002). Efficacy and safety of oral naltrexone treatment for pruritus of cholestasis, a crossover, double blind, placebo-controlled study. J Hepatol. (Placebo controlled cross over trial of 2 weeks of naltrexone for pruritus of liver disease in 20 patients; side effects were dizziness, nausea, headache and abdominal cramps; ALT and AST values decreased).
Romach MK, Sellers EM, Somer GR, Landry M, Cunningham GM, Jovey RD, McKay C, et al. (2002). Naltrexone in the treatment of alcohol dependence: a Canadian trial. Can J Clin Pharmacol. (Open labeled study of naltrexone in 120 alcohol dependent patients; 12% had ALT elevations, but most were attributed to alcoholic liver disease rather than drug).
Guardia J, Caso C, Arias F, Gual A, Sanahuja J, Ramíz M, Mengual I, et al. (2002). A double-blind, placebo-controlled study of naltrexone in the treatment of alcohol-dependence disorder: results from a multicenter clinical trial. Alcohol Clin Exp Res. (Controlled trial of naltrexone vs placebo for 12 weeks in 282 alcohol dependent patients found no hepatic complications and that GGT levels decreased in both groups).
Mason BJ. (2003). Acamprosate and naltrexone treatment for alcohol dependence: an evidence-based risk-benefits assessment. Eur Neuropsychopharmacol. (Review of literature on efficacy and safety of naltrexone and acamprosate for alcohol dependence, mentions that the naltrexone package insert states that it shows a dose dependent hepatotoxicity).
Brewer C, Wong VS. (2004). Naltrexone: report of lack of hepatotoxicity in acute viral hepatitis, with a review of the literature. Addict Biol. (23 year old male heroin abuser developed acute hepatitis B while being treated with depot naltrexone, but subsequently recovered completely without complications; also had chronic hepatitis C).
Bouza C, Angeles M, Muñoz A, Amate JM. (2005). Efficacy and safety of naltrexone and acamprosate in the treatment of alcohol dependence: a systematic review. Addiction 2004; 99: 811-28. Erratum in Addiction. (Systematic review of 33 studies of acamprosate and naltrexone; naltrexone therapy was associated with improvements in GGT and AST levels; no mention of hepatotoxicity).
Galloway GP, Koch M, Cello R, Smith DE. (2005). Pharmacokinetics, safety, and tolerability of a depot formulation of naltrexone in alcoholics: an open-label trial. BMC Psychiatry. (Open label trial of depot naltrexone for 6 weeks in 16 alcohol dependent patients; no serious adverse events were reported and no mention was made of hepatotoxicity or ALT elevations).
Yen MH, Ko HC, Tang FI, Lu RB, Hong JS. (2006). Study of hepatotoxicity of naltrexone in the treatment of alcoholism. Alcohol. (Open label study of 12 weeks of oral naltrexone in 74 alcoholic patients; ALT levels decreased on naltrexone, but one patient had rise of ALT from 12 to 391 U/L; no details provided).
Kim SW, Grant JE, Yoon G, Williams KA, Remmel RP. (2006). Safety of high-dose naltrexone treatment: hepatic transaminase profiles among outpatients. Clin Neuropharmacol. (Open label study of high doses of naltrexone in 41 patients with impulse control disorder, found no change in ALT or AST levels on therapy).
Comer SD, Sullivan MA, Yu E, Rothenberg JL, Kleber HD, Kampman K, Dackis C, et al. (2006). Injectable, sustained-release naltrexone for the treatment of opioid dependence: a randomized, placebo-controlled trial. Arch Gen Psychiatry. (Controlled trial of 8 weeks of depot naltrexone in 60 heroin dependent patients; ALT and GGT levels were stable; 2 patients with significant ALT elevations both had chronic hepatitis C).
Lobmaier P, Kornø Kunø Bjøl A. (2008). Sustained-release naltrexone for opioid dependence. Cochrane Database Syst Rev. (Systematic review of efficacy of naltrexone for opioid dependence; no mention of hepatotoxicity).
Lucey MR, Silverman BL, Illeperuma A, O'Brien CP. (2008). Hepatic safety of once-monthly injectable extended-release naltrexone administered to actively drinking alcoholics. Alcohol Clin Exp Res. (Controlled trial of 6 months of naltrexone by monthly depot injection in 624 patients with alcohol dependence, found no differences in mean ALT or bilirubin levels, but GGT levels were lower on naltrexone; ALT elevations occurred in 9-12% of those on naltrexone vs 15% on placebo).
Garbutt JC. (2010). Efficacy and tolerability of naltrexone in the management of alcohol dependence. Curr Pharm Des. (Review of safety and efficacy of naltrexone for alcohol dependence: in studies of more than 4000 patients, "hepatotoxicity has not emerged as a clinical problem").
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none to naltrexone or other agents used to treated substance abuse).
Yoon G, Kim SW, Thuras P, Westermeyer J. (2011). Safety, tolerability, and feasibility of high-dose naltrexone in alcohol dependence: an open label study. Hum Psychopharmacol. (Among 24 patients undergoing alcohol withdrawal treated with high doses of naltrexone for 12 weeks, serum ALT and bilirubin levels did not change and GGT values fell slightly).
Tetrault JM, Tate JP, McGinnis KA, Coulet JL, Sullivan LE, Bryant K, Justice AC, Fiellin DA, Veterans Aging Cohort Study Team. (2012). Hepatic safety and antiretroviral effectiveness in HIV-infected patients receiving naltrexone. Alcohol Clin Exp Res. (Retrospective analysis of the Veterans Administration database revealed 114 patients with HIV infection who were treated with naltrexone for alcohol dependence for at least 7 days [57% with HCV co-infection, 52% on antiretroviral therapy] showed that ALT levels remained low during naltrexone therapy and only 2 patients had elevations possibly related [Case 1, ALT 225 U/L at day 30 falling to baseline within 2 months of stopping: Case 2, ALT 152 U/L 33 days after stopping, resolving within 4 months]).
Vergara-Rodriguez P, Tozzi MJ, Botsko M, Nandi V, Altice F, Egan JE, O'Connor PG, et al. (2011). BHIVES Collaborative. Hepatic safety and lack of antiretroviral interactions with buprenorphine/naloxone in HIV-infected opioid-dependent patients. J Acquir Immune Defic Syndr. (Among 141 HIV infected subjects treated with buprenorphine/naloxone for 6 months, median serum ALT and AST values did not change and no patient developed clinically apparent liver injury; 3 had transient ALT elevations during treatment [383, 123 and 218 U/L], but all resolved either spontaneously or with drug discontinuation).
Mitchell MC, Memisoglu A, Silverman BL. (2012). Hepatic safety of injectable extended-release naltrexone in patients with chronic hepatitis C and HIV infection. J Stud Alcohol Drugs. (Among 250 opiate dependent patients with high rates of hepatitis C and HIV infection treated with monthly injections of naltrexone or placebo, ALT elevations >3 times ULN occurred in 20% of naltrexone vs 13% of placebo recipients, but all resolved even with continuing the medication).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to naltrexone or other opioid antagonist).
Vagenas P, Di Paola A, Herme M, Lincoln T, Skiest DJ, Altice FL, Springer SA. (2014). An evaluation of hepatic enzyme elevations among HIV-infected released prisoners enrolled in two randomized placebo-controlled trials of extended release naltrexone. J Subst Abuse Treat. (Among 84 individuals with HIV infection recently released from prison who were treated for alcohol or opioid dependency with monthly injections of naltrexone or placebo, none developed clinically apparent liver injury but one subject with HCV co-infection discontinued naltrexone when ALT levels were found to have risen from 27 to 394 U/L after 4 injections).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to naltrexone or other opioid antagonist).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to naltrexone or other opioid antagonist).
Chaignot C, Zureik M, Rey G, Dray-Spira R, Coste J, Weill A. (2018). Risk of hospitalisation and death related to baclofen for alcohol use disorders: Comparison with nalmefene, acamprosate, and naltrexone in a cohort study of 165 334 patients between 2009 and 2015 in France. Pharmacoepidemiol Drug Saf. (Analysis of the French Health Insurance claims database of patients initiating alcohol use disorder therapies found an increased risk of hospitalization [+13%] and death [+31%] compared to exposure to approved drugs such as acamprosate, naltrexone and nalmefene).
(2018). Opioids for pain. Med Lett Drugs Ther. (Concise review of the efficacy, safety and costs of opioids used for pain mentions that the 3 opioid antagonists that are used to treat opioid-induced constipation-methylnaltrexone, naloxegol and nalmedine-have similar degrees of efficacy and toxicities).

## OTHER REFERENCE LINKS

1 Recent References on Naltrexone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Naltrexone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Naltrexone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Naltrexone)